# Pentoxifylline

## OVERVIEW

### Introduction

Pentoxifylline is a xanthine derivative that decreases the viscosity of blood and is used to treat symptoms of intermittent claudication due to peripheral vascular disease. Pentoxifylline has not been associated with serum enzyme elevations during therapy, but in several isolated case reports has been linked to clinically apparent liver injury.

### Background

Pentoxifylline (pen" tox if' i lin) is a small molecular weight methyl derivative of xanthine that appears to act by improving red blood cell deformability, thus reducing blood viscosity as well as decreasing platelet aggregation and thrombus formation. Several prospective controlled trials have shown that pentoxifylline decreases symptoms of intermittent claudication, although its overall effects appear to be modest. Pentoxifylline is a xanthine and also acts as a nonselective inhibitor of phosphodiesterases, which causes an increase in intracellular cyclic AMP and decreased synthesis of tumor necrosis factor alpha and leukotrienes. These antiinflammatory effects have led to its evaluation in several inflammatory liver diseases such as acute and chronic alcoholic hepatitis, nonalcoholic steatohepatitis (NASH), and autoimmune liver diseases. Pentoxifylline was approved in the United States in 1984 after it had been used extensively in other countries for more than a decade. Current indications are limited to symptomatic therapy of intermittent claudication. Pentoxifylline is available by prescription in extended release tablets of 400 mg in several generic forms and under the brand names Trental and Pentoxil. The recommended dose is 400 mg three times daily with meals. Side effects are not uncommon and can include flushing, abdominal discomfort, diarrhea, dyspepsia, nausea, headache, dizziness and blurred vision. Patients with intolerance to xanthines such as caffeine or theophylline may have similar symptoms with pentoxifylline.

### Hepatotoxicity

Chronic therapy with pentoxifylline has not been associated with elevations in serum enzyme levels, although the rigor with which liver test abnormalities were sought in patients taking the drug was not always clear. Despite its use for more than 3 decades, pentoxifylline has been linked to only rare and not completely convincing cases of clinically apparent liver injury. Nevertheless, adverse effects of hepatitis, jaundice, cholestasis and increased liver enzymes are listed in product labels for pentoxifylline. In reported cases, the time to onset was 3 to 4 weeks and the pattern of liver enzyme elevations was distinctly cholestatic (Case 1). Autoimmune and immunoallergic features were not present. The injury was self-limited and there have been no reports of acute liver failure, chronic hepatitis or vanishing bile duct syndrome associated with pentoxifylline therapy.

In addition, pentoxifylline has been evaluated as the therapy of several liver diseases including acute alcoholic hepatitis and cirrhosis, nonalcoholic fatty liver disease and autoimmune liver conditions with varying results. In several small controlled trials in severe acute alcoholic hepatitis, pentoxifylline therapy was associated with a significant decrease in short term mortality and in the frequency of the hepatorenal syndrome. However, in large well controlled trials in alcoholic fatty liver, pentoxifylline with or without corticosteroids was found to have no effect on either short- or long-term mortality and minimal or no effect on rates of renal failure. Pentoxifylline has also been reported to improve serum aminotransferase levels and hepatic histology in adult patients with nonalcoholic steatohepatitis (NASH), but these findings have yet to be tested in larger randomized controlled trials. All studies, however, found pentoxifylline well tolerated in patients with liver disease and without evidence of hepatotoxicity.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which pentoxifylline might cause liver injury is not known. It is metabolized extensively by red blood cells and in the liver, but it does not affect the levels of cytochrome P450 activity.

### Outcome and Management

While pentoxifylline has been reported to cause clinically apparent liver injury, most cases have been mild and self-limited. Several have occurred in patients with a history of intolerance to caffeine and xanthine derivatives. Thus, patients with xanthine hypersensitivity should avoid use of pentoxifylline.

Drug Class: Cardiovascular Drugs, Intermittent Claudication Agents; Xanthine Derivatives

Other Drugs in the Subclass, Intermittent Claudication Agents: Cilostazol

## CASE REPORT

### Case 1. Self-limited cholestatic hepatitis due to pentoxifylline.(1)

An 81 year old woman developed fatigue, nausea and dark urine followed by jaundice 3 weeks after starting pentoxifylline (1200 mg daily) for suspected peripheral vascular disease. She denied a history of liver disease, alcohol abuse and risk factors for viral hepatitis. Her other medical problems included asthma for which she had been using oral theophylline (350 mg daily) and a salbutamol inhaler for many years. She was taking no other medications or herbal products and had no history of drug allergy. On presentation, she was jaundiced but had no organomegaly or signs of chronic liver disease. Laboratory tests showed a total bilirubin of 20.1 mg/dL, ALT 577 U/L, AST 293 U/L, GGT 1361 U/L and alkaline phosphatase 1387 U/L (Table). Serum albumin was low (2.4 g/dL), but the INR was normal. Tests for hepatitis A, B and C and for EBV and CMV were negative. Autoantibodies were not present and immunoglobulin levels were normal. Abdominal ultrasound and CT scans were normal without evidence of biliary obstruction, which was verified by endoscopic retrograde cholangiography. A liver biopsy showed mild portal inflammation and centrilobular (zone 3) cholestasis. Pentoxifylline was stopped and jaundice began to resolve. Eight weeks later she was asymptomatic and all liver tests were normal.

#### Key Points

Medication: | Pentoxifylline
Pattern: | Mixed (R=2.9)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 3 weeks
Recovery: | Complete recovery 2 months after stopping
Other medications: | Theophylline, salbutamol inhalant

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | Pre | Normal | Normal | Normal | [13 years earlier during evaluation for asthma]
4 weeks | 0 | 577 | 1387 | 20.1 | Pentoxifylline stopped
12 weeks | 8 weeks | 29 | 270 | 0.7 | Asymptomatic
Normal Values | | <40 | <279 | <1.2

#### Comment

This was a reasonably convincing case of drug induced, cholestatic hepatitis arising 3 to 4 weeks after starting pentoxifylline. No other cause of jaundice was found despite extensive testing including imaging of the biliary tree by ERCP. While the patient was initially deeply jaundiced, the course was benign and all tests returned to normal within 2 months of stopping pentoxifylline. Interestingly, the patient had asthma and was also taking another xanthine derivative (theophylline) in stable daily doses. Cross sensitivity to other side effects of xanthine derivatives can occur during pentoxifylline therapy, and its combination with full doses of theophylline may have led to excessive xanthine levels and organ toxicity. Cases of hepatitis due to pentoxifylline have been reported to the sponsor, but few have been published and pentoxifylline is not listed in the many large, case series on drug induced liver injury. Thus, hepatotoxicity from pentoxifylline probably occurs, but must be quite rare.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Pentoxifylline – Generic, Pentoxil®, Trental®

DRUG CLASS

Intermittent Claudication Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Pentoxifylline)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Pentoxifylline | 6493-05-6 | C13-H18-N4-O3

## CITED REFERENCE

1 Sáez-Royuela F, López-Vázquez A, López-Morante A, Díez-Sánchez V, Martín-Lorente JL. (1995). Pentoxifylline-induced acute hepatitis. J Hepatol.

## ANNOTATED BIBLIOGRAPHY

References updated: 24 June 2020

Zimmerman HJ. Pentoxifylline. Drugs used in cardiovascular disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 654. (Expert review of hepatotoxicity published in 1999 mentions a single case report of liver injury attributed pentoxifylline [Saez-Royuela 1995] and that several cases have been reported to the FDA).
Eschenhagen T. Treatment of ischemic heart disease. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 489-506. (Textbook of pharmacology and therapeutics mentions that pentoxifylline is called a rheologic modifier for its effects on increasing the deformability of red blood cells, but that its effects on lower extremity claudication are modest).
Di Perri T, Guerrini M. (1983). Placebo controlled double blind study with pentoxifylline of walking performance in patients with intermittent claudication. Angiology. (Among 24 patients with intermittent claudication treated for 30 days, walking performance improved with pentoxifylline but not placebo, and "no adverse reactions were recorded during the trial").
Reich T, Cutler BC, Lee BY, Porter JM, Reichle FA, Scogin JT, Strandness DE. (1984). Pentoxifylline in the treatment of intermittent claudication of the lower limbs. Angiology. (Among 128 patients with intermittent claudication treated with pentoxifylline or placebo for 24 weeks, walking ability improved significantly in the pentoxifylline treated patients and "clinical chemistry findings were not affected").
Roekaerts F, Deleers L. (1984). Trental 400 in the treatment of intermittent claudication: results of long-term, placebo-controlled administration. Angiology. (Among 36 patients with intermittent claudication treated for 6 months, walking performance improved with pentoxifylline but not placebo, and side effects were minor and there were no changes in "laboratory findings").
Aviado DM, Dettelbach HR. (1984). Pharmacology of pentoxifylline: a hemorheologic agent for the treatment of intermittent claudication. Angiology. (Review of the structure, mechanism of action, pharmacology and efficacy of pentoxifylline; no discussion of adverse events, ALT elevations or hepatotoxicity).
Strano A, Davi G, Avellone G, Novo S, Pinto A. (1984). Double-blind, crossover study of the clinical efficacy and the hemorheological effects of pentoxifylline in patients with occlusive arterial disease of the lower limbs. Angiology. (Among 18 patients with intermittent claudication treated for 3 months, walking distance increased by 46% with pentoxifylline vs 4% with placebo, which paralleled changes in blood viscosity; no mention of adverse events).
Gallus AS, Gleadow F, Dupont P, Walsh J, Morley AA, Wenzel A, Alderman M, Chivers D. (1985). Intermittent claudication: a double-blind crossover trial of pentoxifylline. Aust N Z J Med. (Among 38 patients with intermittent claudication treated with pentoxifylline or placebo for 8 weeks, there were no differences in changes in treadmill walking or red blood cell filterability between the two groups).
Reilly DT, Quinton DN, Barrie WW. (1987). A controlled trial of pentoxifylline (Trental 400) in intermittent claudication: clinical, haemostatic and rheological effects. N Z Med J. (Among 30 patients with intermittent claudication treated with pentoxifylline or placebo, both groups had a similar decrease in symptoms and improvement in time to claudication; red blood cell filterability did not correlate with claudication distance).
Cameron HA, Waller PC, Ramsay LE. (1988). Drug treatment of intermittent claudication: a critical analysis of the methods and findings of published clinical trials, 1965-1985. Br J Clin Pharmacol. (Analysis of 75 trials of 33 drugs used to treat intermittent claudication in the English literature [1965-1985] found design problems in 76% of trials and concluded that available information does not support the efficacy of any agent in improving exercise performance in intermittent claudication).
Sáez-Royuela F, López-Vázquez A, López-Morante A, Díez-Sánchez V, Martín-Lorente JL. (1995). Pentoxifylline-induced acute hepatitis. J Hepatol. (81 year old woman developed jaundice 3 weeks after starting pentoxifylline and while receiving theophylline for asthma [bilirubin 20.1 mg/dL, ALT 577 U/L, Alk P 1387 U/L], resolving within 8 weeks of stopping: Case 1).
Dawson DL, Cutler BS, Hiatt WR, Hobson RW, Martin JD, Bortey EB, Forbes WP, et al. (2000). A comparison of cilostazol and pentoxifylline for treating intermittent claudication. Am J Med. (Among 698 patients with intermittent claudication treated with cilostazol [100 mg twice daily], pentoxifylline [400 mg thrice daily] or placebo, maximal walking distance improved more with cilostazol [54%] than pentoxifylline [30%], which was no better than placebo [34%]; adverse events were similar in all 3 groups; no mention of ALT levels or hepatotoxicity).
Akriviadis E, Botla R, Briggs W, Han S, Reynolds T, Shakil O. (2000). Pentoxifylline improves short-term survival in severe acute alcoholic hepatitis: a double-blind, placebo-controlled trial. Gastroenterology. (Among 101 patients with severe alcoholic hepatitis treated with pentoxifylline or placebo for 4 weeks, hospital mortality was 46% in placebo recipients vs 24.5% in pentoxifylline treated subjects, a difference that was sustained during 6 month follow up; there were no drug related serious adverse events or evidence of hepatotoxicity).
Morgan TR, McClain CJ. (2000). Pentoxifylline and alcoholic hepatitis. Gastroenterology. (Editorial in response to Akriviadis [1995] commenting on the dramatic findings of reduced mortality and lower rate of hepatorenal syndrome in those receiving pentoxifylline, and concluding that further evaluation of pentoxifylline in alcoholic liver disease was warranted).
Bharucha AE, Jorgensen R, Lichtman SN, LaRusso NF, Lindor KD. (2000). A pilot study of pentoxifylline for the treatment of primary sclerosing cholangitis. Am J Gastroenterol. (Among 20 patients with sclerosing cholangitis treated with pentoxifylline for up to one year, symptoms and abnormal liver tests did not improve, 2 patients stopped therapy because of symptoms of nausea, but there was no evidence of hepatotoxicity).
De Sanctis MT, Cesarone MR, Belcaro G, Nicolaides AN, Griffin M, Incandela L, Bucci M, et al. (2002). Treatment of intermittent claudication with pentoxifylline: a 12-month, randomized trial--walking distance and microcirculation. Angiology. (Among 101 patients with intermittent claudication treated with pentoxifylline or placebo for 12 months, improvements in walking distance were greater with pentoxifylline than placebo [404% vs 280%] and "no serious drug-related side effects were observed").
Cesarone MR, Belcaro G, Nicolaides AN, Griffin M, De Sanctis MT, Incandela L, Geroulakos G, et al. (2002). Treatment of severe intermittent claudication with pentoxifylline: a 40-week, controlled, randomized trial. Angiology. (Among 178 patients with intermittent claudication treated with pentoxifylline or placebo for 40 weeks, total walking distance improved more pentoxifylline [330% vs 183%] and "no serious drug-related side effects [which would require discontinuation] were observed").
Chapman TM, Goa KL. (2003). Cilostazol: a review of its use in intermittent claudication. Am J Cardiovasc Drugs. (Review of the mechanism of action, efficacy and safety of cilostazol mentions that side effects are common, but generally well tolerated and cilostazol has significant drug-drug interactions with CYP 3A4 and 2C19 inducers; no mention of ALT elevations or hepatotoxicity).
Drugs for intermittent claudication. Med Lett Drugs Ther 2004; 46 1176): 13-5. (Concise review of the medical management of intermittent claudication mentions that pentoxifylline is approved for symptomatic therapy of this condition, but that its efficacy is controversial; no mention of ALT elevations or hepatotoxicity).
Adams LA, Zein CO, Angulo P, Lindor KD. (2004). A pilot trial of pentoxifylline in nonalcoholic steatohepatitis. Am J Gastroenterol. (20 patients with NASH were treated with pentoxifylline or placebo for up to one year, but almost half did not complete therapy because of side effects; ALT and AST levels decreased in patients who continued therapy, but no histology was presented; no mention of hepatotoxicity).
Lee YM, Sutedja DS, Wai CT, Dan YY, Aung MO, Zhou L, Cheng CL, et al. (2008). A randomized controlled pilot study of pentoxifylline in patients with non-alcoholic steatohepatitis (NASH). Hepatol Int. (Among 20 patients with NASH who were treated with pentoxifylline [n=11] or placebo for 12 weeks, improvements in weight, ALT and cytokine levels occurred in both groups).
De BK, Gangopadhyay S, Dutta D, Baksi SD, Pani A, Ghosh P. (2009). Pentoxifylline versus prednisolone for severe alcoholic hepatitis: a randomized controlled trial. World J Gastroenterol. (Among 68 patients with severe acute alcoholic hepatitis treated with pentoxifylline [1200 mg daily] or prednisone [40 mg daily] for 28 days with extension to 3 months, mortality was less with pentoxifylline [15%] than prednisone [35%], the major difference being in fatal hepatorenal syndrome [0% vs 18%]).
Stevens JW, Simpson E, Harnan S, Squires H, Meng Y, Thomas S, Michaels J, et al. (2012). Systematic review of the efficacy of cilostazol, naftidrofuryl oxalate and pentoxifylline for the treatment of intermittent claudication. Br J Surg. (Systematic review of the literature on drugs for intermittent claudication concluded that pentoxifylline was less effective than cilostazol, that adverse events were "generally minor" and that serious adverse events were not increased; no mention of ALT elevations or hepatotoxicity).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to pentoxifylline).
Lebrec D, Thabut D, Oberti F, Perarnau JM, Condat B, Barraud H, Saliba F, et al. (2010). Pentocir Group. Pentoxifylline does not decrease short-term mortality but does reduce complications in patients with advanced cirrhosis. Gastroenterology. (Among 335 patients with alcoholic cirrhosis treated with pentoxifylline or placebo for 6 months, mortality was similar in both groups [30% vs 31%], but liver related complications were less with pentoxifylline [21% vs 37%]; no mention of worsening of ALT levels or hepatotoxicity).
Zein CO, Yerian LM, Gogate P, Lopez R, Kirwan JP, Feldstein AE, McCullough AJ. (2011). Pentoxifylline improves nonalcoholic steatohepatitis: a randomized placebo-controlled trial. Hepatology. (Among 55 patients with NASH treated with pentoxifylline or placebo for 1 year, liver histology improved in 38% vs 14%, and rates of ALT improvement were also higher with pentoxifylline; no mention of hepatotoxicity).
Van Wagner LB, Koppe SW, Brunt EM, Gottstein J, Gardikiotes K, Green RM, Rinella ME. (2011). Pentoxifylline for the treatment of non-alcoholic steatohepatitis: a randomized controlled trial. Ann Hepatol. (Among 30 patients with NASH treated with pentoxifylline or placebo for 12 months, ALT levels and histology scores improved similarly in both groups; there were no severe adverse reactions or worsening of ALT levels).
Sharma BC, Kumar A, Garg V, Reddy RS, Sakhuja P, Sarin SK. (2012). A randomized controlled trial comparing efficacy of pentoxifylline and pioglitazone on metabolic factors and liver histology in patients with non-alcoholic steatohepatitis. J Clin Exp Hepatol. (Among 60 adults with NASH treated with pentoxifylline or pioglitazone for 12 months, ALT levels and liver histology improved in both groups, and there were no differences in adverse reactions and no increases in ALT levels or clinically apparent liver injury).
Sidhu SS, Goyal O, Singla M, Bhatia KL, Chhina RS, Sood A. (2012). Pentoxifylline in severe alcoholic hepatitis: a prospective, randomised trial. J Assoc Physicians India. (Among 50 patients with severe alcoholic hepatitis treated with pentoxifylline or placebo for 4 weeks, mortality was less with pentoxifylline [20% vs 40%] at 4 weeks; the major difference being in deaths accompanied by renal failure).
Saunderson RB, Garsia R, Headley AP, McCaughan GW, O'Toole S, Strasser SI. (2013). Pentoxifylline-induced drug rash with eosinophilia and systemic symptoms (DRESS) in a patient with caffeine intolerance. J Dermatol Case Rep. (39 year of man with severe acute alcoholic hepatitis [bilirubin 20 mg/dL, ALT 64 U/L, AST 328 U/L, Alk P 231 U/L, prothrombin time 18 sec] was treated with pentoxifylline, as well as ticarcillin with clavulanate and developed fever, rash, eosinophilia and worsening hepatic function, improving on stopping both; had a history of caffeine intolerance, but also drug rash from amoxicillin/clavulanate).
Mathurin P, Louvet A, Duhamel A, Nahon P, Carbonell N, Boursier J, Anty R, et al. (2013). Prednisolone with vs without pentoxifylline and survival of patients with severe alcoholic hepatitis: a randomized clinical trial. JAMA. (Among 270 patients with severe alcoholic hepatitis treated with prednisone with or without pentoxifylline for 28 days, 1 and 6 month survival were the same in both groups, although hepatorenal syndrome was less at 4 weeks with pentoxifylline [3% vs 12%]; no mention of possible hepatotoxicity).
Park SH, Kim DJ, Kim YS, Yim HJ, Tak WY, Lee HJ, Sohn JH, et al. (2014). Korean Association for the Study of the Liver (KASL)-Alcohol Related Problems Study Group. Pentoxifylline vs. corticosteroid to treat severe alcoholic hepatitis: a randomised, non-inferiority, open trial. J Hepatol. (Among 121 patients with severe alcoholic hepatitis treated with pentoxifylline or prednisone for 1 month, 1 and 6 month survival rates were not different; no mention of worsening of ALT levels or hepatotoxicity).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to pentoxifylline).
Baniasadi N, Salajegheh F, Pardakhty A, Seyedmirzaee SM, Hayatbakhsh MM, Nikpoor AR, Mohammadi M. (2015). Effects of pentoxifylline on non-alcoholic steatohepatitis: a randomized, double-blind, placebo-controlled trial in Iran. Hepat Mon. (Among 30 patients with nonalcoholic steatohepatitis treated with pentoxifylline or placebo for 24 weeks, ALT levels improved in both groups to a similar degree; no mention of adverse events or ALT elevations).
Thursz MR, Richardson P, Allison M, Austin A, Bowers M, Day CP, Downs N, et al. (2015). STOPAH Trial. Prednisolone or pentoxifylline for alcoholic hepatitis. N Engl J Med. (Among 1053 patients with severe alcoholic hepatitis treated with pentoxifylline or prednisone or both or neither, survival rates at 1, 3 and 12 months were not different in the four groups and there were no differences in rates or types of serious adverse reactions including renal failure [3-5%]).
Thursz M, Forrest E, Roderick P, Day C, Austin A, O'Grady J, Ryder S, et al. (2015). The clinical effectiveness and cost-effectiveness of STeroids Or Pentoxifylline for Alcoholic Hepatitis (STOPAH): a 2 × 2 factorial randomized controlled trial. Health Technol Assess. (Among 1053 patients with acute alcoholic hepatitis treated with pentoxifylline or prednisone or both or placebo, 90 day mortality was similar with or without pentoxifylline [29.1% vs 29.8%] and with or without prednisone [29.8% vs 29.1%], and serious adverse events were frequent but similar with or without pentoxifylline [41% vs 39%]).
Cioboată R, Găman A, Traşcă D, Ungureanu A, Docea AO, Tomescu P, Gherghina F, et al. (2017). Pharmacological management of non-alcoholic fatty liver disease: atorvastatin versus pentoxifylline. Exp Ther Med. (Among 98 patients with nonalcoholic fatty liver disease treated with atorvastatin [if dyslipidemic] or pentoxifylline [if not] for an average of 32 weeks, ALT and steatosis scores improved in both groups; no mention of adverse events).
Alam S, Nazmul Hasan S, Mustafa G, Alam M, Kamal M, Ahmad N. (2017). Effect of pentoxifylline on histological activity and fibrosis of nonalcoholic steatohepatitis patients: a one year randomized control trial. J Transl Int Med. (Among 35 patients with nonalcoholic steatohepatitis treated with pentoxifylline [400 mg twice daily] or placebo for 1 year, ALT and AST levels improved in both groups and to a similar degree as did steatosis; no mention of hepatic adverse events).
Stine JG, Wang J, Cornella SL, Behm BW, Henry Z, Shah NL, Caldwell SH, Northup PG. (2018). Treatment of type-1 hepatorenal syndrome with pentoxifylline: a randomized placebo controlled clinical trial. Ann Hepatol. (Among 12 patients with cirrhosis and hepatorenal syndrome treated with pentoxifylline or placebo for up to 10 days, the two groups were similar in rates of resolution of renal dysfunction and overall survival, while pentoxifylline was well tolerated in these very ill patients with no adverse events attributed to its use).

## OTHER REFERENCE LINKS

1 Recent References on Pentoxifylline: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(pentoxifylline)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222010/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Pentoxifylline: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=pentoxifylline)